# Triptorelin

## OVERVIEW

### Introduction

Triptorelin is a gonadotropin releasing hormone (GnRH) agonist that is a potent inhibitor of the synthesis of testosterone (in men) and estrogen (in women) and is used to treat advanced prostate cancer. Triptorelin is associated with a low rate of transient serum enzyme elevations during therapy, but has not been linked convincingly to cases of clinically apparent acute liver injury.

### Background

Triptorelin (trip" toe rel' in) is a decapeptide analogue of gonadotropin releasing hormone (GnRH) that acts on the pituitary to cause the synthesis and release of luteinizing hormone (LH) and follicle stimulating hormone (FSH), two gonadotropins that act on the male testes to stimulate the production of testosterone and on the female ovaries to induce synthesis of estrogen. Triptorelin and other GnRH agonists cause an initial surge of gonadotropin release, but then lead to down-regulation of their synthesis and secretion which results in a decline in testosterone and estrogen production. Triptorelin, alone or in combination with other antiandrogens, has been found to be palliative in advanced prostate cancer and as effective as surgical castration. Triptorelin was approved for use in the United States for prostate cancer in 2000 and is still widely used, being considered a first line treatment of this hormone responsive malignancy. The GnRH agonists have also been used off label for precocious puberty, infertility, and as a part of gender affirming therapy. Triptorelin is available generically and under the brand name Trelstar in an injectable suspension for intramuscular depot administration every 4 weeks (3.75 mg), 12 weeks (11.25 mg) or 24 weeks (22.5 mg). Triptorelin and the other GnRH analogues cause a profound hypogonadism ("chemical castration") and its common side effects are typical of androgen deprivation, including hot flashes, loss of libido, erectile dysfunction, depression, nausea, diarrhea, weight gain and fluid retention. Rare, but potentially severe adverse events can include immediate hypersensitivity reactions, pituitary apoplexy and, with long term use, weight gain, metabolic changes, diabetes and osteoporosis.

### Hepatotoxicity

Long term triptorelin is associated with serum enzyme elevations in 2% to 5% of patients, although the elevations are rarely above three times the upper limit of normal (<1%). The enzyme elevations are usually mild, asymptomatic and resolve even without dose modification or drug discontinuation. Triptorelin has not been linked convincingly to cases of acute, clinically apparent liver injury with jaundice.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the minor serum enzyme elevations that can occur during triptorelin therapy is unknown. Triptorelin is a decapeptide similar to GnRH and is metabolized locally in tissue and not by the hepatic cytochrome P450 system. Some serum enzyme elevations may be caused by nonalcoholic fatty liver arising because of weight gain or metabolic changes caused by the androgen deprivation state induced by the GnRH agonist.

### Outcome and Management

The serum enzyme elevations during triptorelin therapy rarely require dose modification or drug discontinuation and should instead lead to investigation of other possible causes of liver injury. There is no evidence to indicate that there is cross sensitivity to liver injury among the various GnRH analogues.

Drug Class: Antineoplastic Agents, GnRH Analogues

Other Drugs in the Subclass, GnRH Analogues: Degarelix, Goserelin, Histrelin, Leuprolide, Relugolix

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Triptorelin – Generic, Trelstar®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Triptorelin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Triptorelin | 57773-63-4 | C64-H82-N18-O13

## ANNOTATED BIBLIOGRAPHY

References updated: 28 May 2023

Abbreviations: FSH, follicle stimulating hormone; GnRH, gonadotropin releasing hormone; LH, luteinizing hormone; PSA, prostate specific antigen.

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 699. (Expert review of hepatotoxicity published in 1999; the GnRH analogues such as triptorelin are not discussed).
Chitturi S, Farrell GC. Estrogen receptor antagonists. Adverse effects of hormones and hormone antagonists on the liver. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 610-2. (Review of hepatotoxicity of hormonal products; does not discuss the GnRH agonists such as triptorelin).
Levin ER, Vitek WS, Hammes SR. Estrogens, progestins, and the female reproductive tract. In, Brunton LL, Halal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 803-31. (Textbook of pharmacology and therapeutics).
Snyder PJ. Androgens and the male reproductive tract. In, Brunton LL, Halal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 833-43. (Textbook of pharmacology and therapeutics).
Isaacs C, Wellstein A, Riegel AT. Hormones and related agents in the therapy of cancer. In, Brunton LL, Halal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1237-47. (Textbook of pharmacology and therapeutics).
(2002). Triptorelin pamoate (Trelstar). Med Lett Drugs Ther. (Concise review of the mechanism of action, efficacy, safety and costs of triptorelin for prostate cancer shortly after its approval in the US; mentions that adverse effects are similar to those of goserelin; does not mention ALT elevations or hepatotoxicity).
Heyns CF, Simonin MP, Grosgurin P, Schall R, Porchet HC, South African Triptorelin Study Group. (2003). Comparative efficacy of triptorelin pamoate and leuprolide acetate in men with advanced prostate cancer. BJU Int. (Among 284 men with prostate cancer treated with triptorelin or leuprolide in 9 monthly injections, both beneficial and adverse effects were similar and "there were no substantial changes in laboratory data"; ALT levels were not specifically mentioned).
Carel JC, Blumberg J, Seymour C, Adamsbaum C, Lahlou N. (2006). Triptorelin 3-month CPP Study Group. Three-month sustained release triptorelin (11.25 mg) in the treatment of central precocious puberty. Eur J Endocrinol. (Among 64 children [54 girls] with central precocious puberty treated with triptorelin acetate depot injections every 3 months for 1 year, pubertal regression occurred in most subjects and adverse events were generally mild and self-limited; no mention of ALT elevations or hepatotoxicity).
Lundström EA, Rencken RK, van Wyk JH, Coetzee LJ, Bahlmann JC, Reif S, Strasheim EA, et al. (2009). Triptorelin 6-month formulation in the management of patients with locally advanced and metastatic prostate cancer: an open-label, non-comparative, multicentre, phase III study. Clin Drug Investig. (Among 120 patients given triptorelin in 6-month formulation [22.5 mg] for one year, the most common side effects were hot flashes [72%], erectile dysfunction [10%] and injection site reactions [7%], and one patient had a rise in ALT levels [peak=60 U/L] on day 337).
Rabaglio M, Ruepp B, Soft/Text/Perche Steering Committee. (2010). Death due to liver failure during endocrine therapy for premenopausal breast cancer. Acta Oncol. (Among 4500 women enrolled in an international trial of endocrine therapy of premenopausal breast cancer comparing tamoxifen and exemestane combined with ovarian suppression often with triptorelin, 2 developed liver failure: 50 year old on endocrine therapy for two years developed suspected acute alcoholic hepatitis and died 1 month later [bilirubin 23.2 mg/dL, ALT 182 U/L, AST 294 U/L, GGT 2623 U/L, Alk P 382 U/L]; 36 year old woman on endocrine therapy including tamoxifen for 3 years developed nonspecific symptoms and hepatomegaly and died suddenly, autopsy showing cirrhosis with steatosis, possibly due to or exacerbated by tamoxifen; in neither case could triptorelin be convincingly implicated).
Crawford ED, Phillips JM. (2011). Six-month gonadotropin releasing hormone (GnRH) agonist depots provide efficacy, safety, convenience, and comfort. Cancer Manag Res. (Review of results on two GnRH agonist depot formulations for advanced prostate cancer that allow for every 6-month administration [leuprolide and triptorelin], both of which provide sustained testosterone suppression and have adverse side effects similar to other GnRH agonist formulations; mentions a single episode of minor asymptomatic ALT [60 U/L] and AST [65 U/L] elevations in a patient receiving triptorelin [Ludström 2009]).
Del Mastro L, Boni L, Michelotti A, Gamucci T, Olmeo N, Gori S, Giordano M, et al. (2011). Effect of the gonadotropin-releasing hormone analogue triptorelin on the occurrence of chemotherapy-induced early menopause in premenopausal women with breast cancer: a randomized trial. JAMA. (Among 181 premenopausal women with breast cancer treated with chemotherapy alone or combined with triptorelin [for 6 months], early onset of menopause was less common with triptorelin therapy [9% vs 26%] and adverse events were similar in the two groups; no mention of ALT elevations or hepatotoxicity).
Boccon-Gibod L, van der Meulen E, Persson BE. (2011). An update on the use of gonadotropin-releasing hormone antagonists in prostate cancer. Ther Adv Urol. (GnRH antagonists such as degarelix have similar efficacy to GnRH agonists in therapy of prostate cancer but have a more rapid onset of action and do not cause the initial testosterone surge that occurs with the agonists, which can be particularly troublesome in patients with a large tumor burden).
Van Poppel H, Klotz L. (2012). Gonadotropin-releasing hormone: an update review of the antagonists versus agonists. Int J Urol. (Review of androgen deprivation therapy for prostate cancer using GnRH agonists and antagonists stressing the more rapid onset of action and similar if not better safety profile of GnRH antagonists).
Walker LM, Tran S, Robinson JW. (2013). Luteinizing hormone--releasing hormone agonists: a quick reference for prevalence rates of potential adverse effects. Clin Genitourin Cancer. (Systematic review of adverse event profile of long-term use of GnRH agonists which mostly relate to hypogonadism: hot flashes, gynecomastia, genital shrinkage, hair loss, osteoporosis, mild anemia, hyperglycemia, increased weight, loss of skeletal muscle mass, emotional lability, depression, loss of sexual desire and erectile dysfunction; no mention of ALT elevations or hepatotoxicity).
Ploussard G, Mongiat-Artus P. (2013). Triptorelin in the management of prostate cancer. Future Oncol. (Review of the efficacy and safety of triptorelin as therapy of prostate cancer focusing upon 1 vs 3 vs 6 monthly formulations; no mention of ALT elevations or hepatotoxicity).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to triptorelin or any of the GnRH analogues).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e.7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to triptorelin or any of the GnRH analogues).
Lambertini M, Boni L, Michelotti A, Gamucci T, Scotto T, Gori S, Giordano M, et al., GIM Study Group. (2015). Ovarian suppression with triptorelin during adjuvant breast cancer chemotherapy and long-term ovarian function, pregnancies, and disease-Free survival: a randomized clinical trial. JAMA. (Among 281 premenopausal women with breast cancer treated with chemotherapy with or without triptorelin [Del Mastro 2011], long term disease-free survival rates were similar while rates of menstrual resumption were slightly higher with triptorelin; no mention of adverse events, ALT elevations or hepatotoxicity).
Zenaty D, Blumberg J, Liyanage N, Jacqz-Aigrain E, Lahlou N, Carel JC. (2016). Co-Investigators. A 6-month trial of the efficacy and safety of triptorelin pamoate (11.25 mg) every 3 months in children with precocious puberty: a retrospective comparison with triptorelin acetate. Horm Res Paediatr. (Among 37 children with precocious puberty treated with triptorelin pamoate depot injections every 3 months, pubertal regression occurred in most and adverse events were generally mild and self-limited: no mention of ALT elevations or hepatotoxicity).
Schagen SE, Cohen-Kettenis PT, Delemarre-van de Waal HA, Hannema SE. (2016). Efficacy and Safety of gonadotropin-releasing hormone agonist treatment to suppress puberty in gender dysphoric adolescents. J Sex Med. (Among 49 male-to-female and 67 female-to-male gender dysphoric adolescents treated with triptorelin for at least 6 months, ALT and AST elevations were present in 5% to 10% of subjects at baseline and levels did not change during treatment, however, growth velocity slowed, and lean body mass decreased while fat percentage increased).
Bolton EM, Lynch TH. (2018). Are all gonadotropin-releasing hormone agonists equivalent for the treatment of prostate cancer? A systematic review. BJU Int. (Systematic review of literature on relative efficacy and safety of different GnRH agonists, indicates that there is little evidence of superiority of any of the four, largely because of lack of adequately powered, controlled studies comparing them).
Cornford P, Jefferson K, Cole O, Gilbody J. (2018). Effects of initiating or switching to a six-monthly triptorelin formulation on prostate cancer patient-healthcare interactions and hospital resource use: a real-world, retrospective, non-interventional study. Oncol Ther. (Among 41 adults with advanced prostate cancer who were switched from every 1 or 3 monthly GnRH regimen to 6 monthly triptorelin, healthcare visits, injections and PSA testing were less as were adverse side effects including fatigue [12% vs 26%], urinary frequency [9% vs 32%], and bone pain [7% vs 14%]; no mention of ALT elevations or hepatotoxicity).
Lambertini M, Boni L, Michelotti A, Magnolfi E, Cogoni AA, Mosconi AM, Giordano M, et al., GIM study group. (2022). Long-term outcomes with pharmacological ovarian suppression during chemotherapy in premenopausal early breast cancer patients. J Natl Cancer Inst. (Among 281 women with early onset breast cancer treated with chemotherapy with or without a GnRH analogue to preserve ovarian function, disease-free and overall survival were similar in the two groups and those given the GnRH analogue were slightly more likely to have a successful pregnancy during follow up [6.5% vs 3.2%]; no mention of other adverse events, ALT levels or hepatotoxicity).
Popovic J, Geffner ME, Rogol AD, Silverman LA, Kaplowitz PB, Mauras N, Zeitler P, et al. (2022). Gonadotropin-releasing hormone analog therapies for children with central precocious puberty in the United States. Front Pediatr. (Review of the 3 GnRH analogues used to treat children with precocious puberty including leuprolide, triptorelin, and histrelin which have different regimens of administration [intramuscular and subcutaneous] and durations of action [1-12 months]; no mention of liver adverse events).

## OTHER REFERENCE LINKS

1 Recent References on Triptorelin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Triptorelin+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Triptorelin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Triptorelin)